# Temozolomide

## OVERVIEW

### Introduction

Temozolomide is an orally administered alkylating agent used largely in the therapy of malignant brain tumors including glioblastoma and astrocytoma. Temozolomide has been associated with a low rate of serum enzyme elevations during treatment and with rare instances of clinically apparent cholestatic liver injury.

### Background

Temozolomide (tem" oh zol' oh mide) is an imidazotetrazine derivative similar to dacarbazine (DTIC), which acts as an alkylating agent disrupting DNA replication, causing modification and cross linking of DNA, thus inhibiting DNA, RNA and protein synthesis and causing programmed cell death (apoptosis) in rapidly dividing cells. Temozolomide rapidly crosses the blood-brain barrier and has been evaluated largely in the therapy of malignant brain tumors. Temozolomide has been shown to induce tumor regression and remissions in patients with malignant astrocytoma and glioblastoma multiforme. It may also have activity in melanoma. Temozolomide was approved for use in the United States in 1999 and is now commonly used in treating patients with malignant brain tumors. Temozolomide is available in capsules of 5, 20, 100, 140, 180 and 250 mg and as a solution for injection generically and under the brand name of Temodar. The recommended dose regimen is calculated based on phase (initial cycles, maintenance), body weight, bone marrow toxicity and tolerance. It is typically given in a dose of 150 mg/m^2^ once a day during concurrent radiation therapy for 42 days followed by 75 mg/m^2^ on days 1 to 5 of each 28 day cycle. Temozolomide is considered somewhat less toxic and better tolerated than many other alkylating agents, but does have the common side effects of fatigue, nausea and vomiting, gastrointestinal upset, alopecia and bone marrow suppression. Less common but potentially severe adverse events included severe myelosuppression, myelodysplastic syndromes, pneumocystis pneumonia, hepatotoxicity and embryo-fetal toxicity.

### Hepatotoxicity

Serum aminotransferase elevations occur during temozolomide therapy in up to 12% of patients, but these elevations are usually mild and self-limited, not requiring dose adjustment or drug discontinuation. An instance of serum aminotransferase elevation with jaundice was reported in the registration trials of temozolomide and subsequent to its approval. More strikingly, multiple single case reports and several case series of temozolomide hepatotoxicity have been reported in the literature. The onset of injury was typically within 2 to 8 weeks of starting temozolomide but several patients had received multiple courses before the onset of liver injury. The pattern of serum enzyme elevations was usually mixed initially, but the disease tended to be cholestatic. In several instances, jaundice was deep and prolonged. Features of hypersensitivity (rash, fever, eosinophilia) and autoantibody formation were not present. Liver histology demonstrated cholestasis and bile duct injury and a striking decrease in bile ducts (bile duct loss or paucity). Jaundice and pruritus tended to be prolonged and some patients developed vanishing bile duct syndrome, while others recovered clinically but had persistent serum alkaline phosphatase elevations during follow up and to the time of death from the brain tumor. Rechallenge was not done, but several patients subsequently received other antineoplastic agents, some of which were alkylating agents without recurrence of liver injury.

In addition, temozolomide has been associated with several cases of reactivation of chronic hepatitis B in patients who were hepatitis B surface antigen (HBsAg) positive at the start of chemotherapy. Clinical symptoms and signs of a flare of hepatitis B arose 6 to 12 weeks after starting temozolomide frequently in a cyclic pattern. Most patients had not received corticosteroids or other immunosuppressive agents that are more traditionally associated with reactivation. The episodes are marked by rises in HBV DNA levels and mild jaundice and responded to prompt antiviral therapy for hepatitis B which allowed for restarting of temozolomide in some cases. Fatal cases of reactivation have not been reported, but in general hepatitis B reactivation with jaundice has a mortality rate in excess of 10%.

Likelihood score: B (highly likely but uncommon cause of clinically apparent liver injury and reactivation of hepatitis B).

### Mechanism of Injury

Temozolomide is hydrolyzed to the active intermediate at physiological pH and does not require hepatic metabolism or affect the cytochrome P450 (CYP) system to a major degree, perhaps accounting for its relative lack of direct hepatotoxicity. The cases of acute cholestatic liver injury have resembled idiosyncratic drug induced liver injury.

### Outcome and Management

The severity of liver injury caused by temozolomide ranges from minor transient elevations in serum enzymes to severe cholestatic hepatitis that can be prolonged. Temozolomide has not been reported to cause acute liver failure but has been linked to instances of chronic liver injury and paucity of bile ducts on liver biopsy suggestive of mild vanishing bile duct syndrome. Because temozolomide is used as therapy of highly malignant brain tumors, long term follow up of liver injury from its use is rarely available. Most patients recover clinically, but may persist in having mild and asymptomatic alkaline phosphatase elevations. There is no evidence for cross sensitivity to hepatic injury between temozolomide and other alkylating agents. Because temozolomide has been linked to instances of reactivation of hepatitis B, it is appropriate to screen all patients scheduled to receive temozolomide for HBsAg and anti-HBc. Patients with serologic evidence of ongoing or previous hepatitis B should be monitored for evidence of reactivation (rise in HBV DNA). If evidence of reactivation arises, prompt therapy with an antiviral with potent activity against HBV is appropriate (such as entecavir or tenofovir). An alternative approach is to use the antiviral agent prophylactically in such patients. The antiviral therapy (either as prophylaxis or treatment) should be continued as long as the chemotherapy is planned and for 3 to 6 months thereafter.

Drug Class: Antineoplastic Agents, Alkylating Agents

## CASE REPORT

### Case 1. Severe mixed hepatocellular-cholestatic hepatitis due to temozolomide.(1)

A 67 year old woman developed jaundice 40 days after starting temozolomide therapy of a malignant glioblastoma. She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. She had undergone resection of a left temporal lobe brain tumor 3 months earlier at which time she received local radiation and dexamethasone. Shortly thereafter she was started on temozolomide and levetiracetam along with dexamethasone (6 mg daily). She was also prescribed pantoprazole (40 mg daily) and ondansetron (4 mg orally as needed). Her past medical history was otherwise unremarkable, and she denied previous drug allergies. For many years, she had used a daily transdermal estradiol (0.0375 mg) patch and taken calcium, vitamin D and a multivitamin. When the jaundice was detected, she admitted to mild fatigue, but specifically denied fever, rash, itching, abdominal pain, anorexia or nausea. On examination, she was jaundiced but had no fever, rash, hepatic enlargement or tenderness. Laboratory tests showed a total bilirubin of 7.7 (6.6 mg/dL direct), ALT 896 U/L, AST 262 U/L, alkaline phosphatase 427 U/L and serum albumin 3.3 g/dL. Her serum ALT levels had been slightly abnormal at the time of her craniotomy, before temozolomide therapy (Table). Levetiracetam was stopped but temozolomide was continued. She developed deepening jaundice and serum enzyme elevations continued to rise, whereupon temozolomide was also stopped. Tests for hepatitis A, B and C (including HCV RNA and HBV DNA) were negative as were autoantibodies. Abdominal ultrasound showed no evidence of biliary obstruction. A liver biopsy showed marked cholestatic hepatitis with bile duct damage suggestive of drug induced liver injury. There was no reduction in the number of bile ducts. Serum bilirubin levels peaked at 46.8 mg/dL, ALT at 2783 U/L and alkaline phosphatase at 1219 U/L approximately 14 days after temozolomide was discontinued. Thereafter, serum bilirubin and enzymes slowly improved. Despite the height of the serum bilirubin and ALT, the prothrombin time remained normal and she had no signs of hepatic encephalopathy and continued to deny symptoms of abdominal pain, nausea or itching. Jaundice resolved after 3 months and liver tests were minimally abnormal 12 months later. Because of reappearance of seizures, levetiracetam was restarted without recurrence of jaundice or worsening of liver tests. Temozolomide was not restarted.

#### Key Points

Medication: | Temozolomide
Pattern: | Hepatocellular-mixed (R=5.8, falling to 2.1 at time of peak bilirubin)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 5-6 weeks
Recovery: | 6 months
Other medications: | Levetiracetam

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 67 | 68 | 0.4
2 weeks | 0 | 74 | 63 | 0.4
6 weeks | 0 | 896 | 427 | 7.7 | Protime 12.9 seconds
7 weeks | 1 week | 2444 | 1142 | 24.3 | Liver biopsy
8 weeks | 2 weeks | 2351 | 975 | 37.8 | Ursodiol started
9 weeks | 3 weeks | 1218 | 1557 | 44.8
10 weeks | 4 weeks | 627 | 1245 | 29.9
3 months | 6 weeks | 366 | 565 | 6.8
4 months | 2 months | 212 | 334 | 2.6
| 4 months | 243 | 263 | 0.8
| 6 months | 134 | 256 | 0.6 | Levetiracetam restarted
| 8 months | 117 | 195 | 0.6
14 months | 12 months | 37 | 141 | 0.5
Normal Values | | <42 | <115 | <1.2

#### Comment

Cholestatic hepatitis arose after 6 weeks of therapy with temozolomide and levetiracetam. Both drugs were stopped, but recovery was delayed. A liver biopsy showed cholestasis and bile duct injury, but importantly did not show massive or submassive necrosis. The patient had few symptoms but biochemical recovery was delayed. Levetiracetam (which rarely causes liver injury) was restarted without worsening of the liver condition, making the diagnosis of temozolomide induced liver injury more likely. While the liver injury ultimately resolved, it did cause an interruption of therapy and significantly disturbed the quality of life in an already compromised patient.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Temozolomide – Generic, Temodar®

DRUG CLASS

Antineoplastic Agents, Alkylating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Temozolomide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Temozolomide | 85622-93-1 | C6-H6-N6-O2

## CITED REFERENCE

1 Clinical Center, National Institutes of Health.

## ANNOTATED BIBLIOGRAPHY

References updated: 02 September 2020

Zimmerman HJ. Alkylating agents: hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 678-80. (Expert review of hepatotoxicity of alkylating agents published in 1999 before the general availability of temozolomide).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 549-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; does not discuss temozolomide specifically).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Cytotoxic agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1167-1201. (Textbook of pharmacology and therapeutics: "Temozolomide is the standard agent in combination with radiation therapy for patients with malignant glioma and for astrocytoma").
(1999). Temozolomide for refractory anaplastic astrocytoma. Med Lett Drugs Ther. (Concise summary of efficacy of temozolomide in therapy of astrocytoma, the basis of its accelerated approval from the FDA in 1999; no mention of hepatotoxicity).
Yung WK, Prados MD, Yaya-Tur R, Rosenfeld SS, Brada M, Friedman HS, Albright R, et al. (1999). Multicenter phase II trial of temozolomide in patients with anaplastic astrocytoma or anaplastic oligoastrocytoma at first relapse. Temodal Brain Tumor Group. J Clin Oncol. (Open label multicenter trial of temozolomide in 162 patients with astrocytoma; most common side effects were nausea, headache, fatigue, thrombocytopenia and neutropenia; no mention of ALT elevations or hepatotoxicity).
Stupp R, Mason WP, van den Bent MJ, Weller M, Fisher B, Taphoorn MJ, Belanger K, et al., European Organisation for Research and Treatment of Cancer Brain Tumor and Radiotherapy Groups. (2005). National Cancer Institute of Canada Clinical Trials Group. Radiotherapy plus concomitant and adjuvant temozolomide for glioblastoma. N Engl J Med. (Controlled trial of temozolomide and radiation vs radiation alone in 573 patients with glioblastoma showing increase in 2 year survival [26% vs 10%]; severe side effects included bone marrow suppression, fatigue, thromboembolism and infections; no mention of hepatotoxicity, jaundice or ALT elevations).
Yang SH, Kim MK, Lee TK, Lee KS, Jeun SS, Park CK, Kang JK, et al. (2006). Temozolomide chemotherapy in patients with recurrent malignant gliomas. J Korean Med Sci. (Open label study of temozolomide in 25 Korean patients with recurrent gliomas; ALT elevations occurred in 12% of patients and one patient with preexisting liver disease developed "grade 2" toxicity).
Dario A, Tomei G. (2006). The safety of the temozolomide in patients with malignant glioma. Curr Drug Saf. (Systematic review of the literature on the safety and adverse effects of temozolomide; the major toxicity is myelosuppression; common minor side effects are nausea, vomiting and fatigue; infections occur in 1 to 6% of treated patients; no discussion of hepatotoxicity).
Grewal J, Dellinger CA, Yung WK. (2007). Fatal reactivation of hepatitis B with temozolomide. N Engl J Med. (65 year old woman with glioblastoma developed jaundice 3 months after starting temozolomide and radiation therapy [bilirubin 2.8 rising to 25.9 mg/dL, ALT 1338 U/L, Alk P 107 U/L, HBV DNA above 500 million copies/mL], progressing to hepatic failure and death despite entecavir therapy; status of HBsAg before therapy was not reported).
Chheda MG, Drappatz J, Greenberger NJ, Kesari S, Weiss SE, Gigas DC, Doherty LM, et al. (2007). Hepatitis B reactivation during glioblastoma treatment with temozolomide: a cautionary note. Neurology. (50 year old man with glioblastoma developed jaundice 6-8 weeks after starting radiation and chemotherapy with temozolomide and dexamethasone [bilirubin 2.9 mg/dL, ALT 1728 U/L, Alk P 109 U/L, HBV DNA 724,000 copies/mL], improving with lamivudine therapy and later tolerating temozolomide without recurrence of reactivation).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, antineoplastic agents were rarely implicated: 3 were considered due to mercaptopurine and 1 each due to bortezomib, cyclophosphamide, docetaxel, and temozolomide).
Neyns B, Hoorens A, Stupp R. (2008). Valproic acid related idiosyncratic drug induced hepatotoxicity in a glioblastoma patient treated with temozolomide. Acta Neurol Belg. (48 year old patient developed cholestatic hepatitis during therapy with temozolomide, cilengitide and valproate which improved when all drugs were stopped and did not recur with restarting temozolomide).
Trinh VA, Patel SP, Hwu WJ. (2009). The safety of temozolomide in the treatment of malignancies. Expert Opin Drug Saf. (Extensive review of pharmacology, clinical efficacy, and safety of temozolomide; dose limiting toxicity is bone marrow suppression; no mention of hepatotoxicity or ALT elevations).
Clarke JL, Iwamoto FM, Sul J, Panageas K, Lassman AB, DeAngelis LM, Hormigo A, et al. (2009). Randomized phase II trial of chemoradiotherapy followed by either dose-dense or metronomic temozolomide for newly diagnosed glioblastoma. J Clin Oncol. (Among 85 patients with glioblastoma treated with temozolomide, ALT or AST elevations occurred in 6% of patients overall, more commonly with continuous daily dosing [5 of 28: 18%] than cyclic dosing [1 of 31: 3%]).
Perry JR, Bélanger K, Mason WP, Fulton D, Kavan P, Easaw J, Shields C, et al. (2010). Phase II trial of continuous dose-intense temozolomide in recurrent malignant glioma: RESCUE study. J Clin Oncol. (Among 120 patients with recurrent glioblastoma treated with temozolomide for 0.3-24 months, nonhematologic toxicities were mild; no mention of ALT elevations or hepatotoxicity).
Seiz M, Krafft U, Freyschlag CF, Weiss C, Schmieder K, Lohr F, Wenz F, et al. (2010). Long-term adjuvant administration of temozolomide in patients with glioblastoma multiforme: experience of a single institution. J Cancer Res Clin Oncol. (Among 114 patients with glioblastoma treated with long term temozolomide, treatment was stopped in 34% because of hematologic side effects, but in none for liver related toxicities; no mention of ALT levels).
Goldbecker A, Tryc AB, Raab P, Worthmann H, Herrmann J, Weissenborn K. (2011). Hepatic encephalopathy after treatment with temozolomide. J Neurooncol. (66 year old woman with glioblastoma developed jaundice 2 months after starting temozolomide [bilirubin 20.8 mg/dL, ALT 410 U/L, Alk P 2009 U/L], liver biopsy showing cholestasis and steatosis with slow and incomplete recovery).
Gállego Pérez-Larraya J, Ducray F, Chinot O, Catry-Thomas I, Taillandier L, Guillamo JS, Campello C, et al. (2011). Temozolomide in elderly patients with newly diagnosed glioblastoma and poor performance status: an ANOCEF phase II trial. J Clin Oncol. (Among 77 elderly patients with glioblastoma treated with temozolomide, one developed ALT elevations >5 times ULN, but no specific details given).
Niewald M, Berdel C, Fleckenstein J, Licht N, Ketter R, Rübe C. (2011). Toxicity after radiochemotherapy for glioblastoma using temozolomide--a retrospective evaluation. Radiat Oncol. (Retrospective analysis of 46 patients with glioblastoma treated with radiation and temozolomide found ALT elevations [>5 times ULN] in 5 patients [11%], leading to discontinuation in 2).
Ohno M, Narita Y, Miyakita Y, Ueno H, Kayama T, Shibui S. (2011). Reactivation of hepatitis B virus after glioblastoma treatment with temozolomide--case report. Neurol Med Chir (Tokyo). (51 year old HBsAg positive man with glioblastoma developed reactivation of hepatitis B 10 weeks after starting chemotherapy [bilirubin not given, ALT rising from 28 to 744 U/L, HBV DNA from 3.8 to 5.8 log copies/mL], responding to entecavir therapy).
Dixit S, Hingorani M, Afzal P, Campbell AP. (2011). Temozolomide induced liver injury. Acta Neurol Belg. (62 year old woman with glioblastoma developed jaundice 6 weeks after starting radiation therapy and temozolomide [bilirubin 1.9 mg/dL, ALT 2610 U/L, Alk P 1240 U/L], with prolonged cholestasis).
Sarganas G, Orzechowski HD, Klimpel A, Thomae M, Kauffmann W, Herbst H, Bronder E, Garbe E. (2012). Severe sustained cholestatic hepatitis following temozolomide in a patient with glioblastoma multiforme: case study and review of data from the FDA adverse event reporting system. Neuro Oncol. (51 year old man with glioblastoma developed jaundice 6 weeks after starting temozolomide [bilirubin ~13.0 mg/dL, ALT 639 U/L, Alk P 261 U/L], with persistent jaundice until death from cancer 1 year later).
Zamani N, Mohammad Alizadeh A. (2012). Drug-induced cholestatic hepatitis: how late can it occur even after the cessation of the culpable drug?. Neuro Oncol. (Letter in response to Sarganas [2012] suggesting acetaminophen as the cause of the liver injury).
Wick W, Platten M, Meisner C, Felsberg J, Tabatabai G, Simon M, Nikkhah G, et al., NOA-08 Study Group of Neuro-oncology Working Group (NOA) of German Cancer Society. (2012). Temozolomide chemotherapy alone versus radiotherapy alone for malignant astrocytoma in the elderly: the NOA-08 randomised, phase 3 trial. Lancet Oncol. (Controlled trial of temozolomide alone vs radiotherapy alone in 373 elderly patients with astrocytoma found similar efficacy; grade 3 enzyme elevations occurred in 30% of temozolomide vs 16% of radiation treated subjects).
Fujimoto Y, Hashimoto N, Kinoshita M, Miyazaki Y, Tanaka S, Yakushijin T, Takehara T, et al. (2012). Hepatitis B virus reactivation associated with temozolomide for malignant glioma: a case report and recommendation for prophylaxis. Int J Clin Oncol. (49 year old HBsAg positive woman with glioma developed reactivation of hepatitis B 2 months after starting chemotherapy with temozolomide and radiation without corticosteroids [bilirubin 1.4 mg/dL, ALT 1098 U/L, Alk P 515 U/L, HBV DNA 1 billion copies/mL], responding to entecavir; temozolomide not restarted).
Miller RJ, Gui X, Easaw JC, Tsang RY. (2012). Chemotherapy-associated steatohepatitis with temozolomide and dexamethasone. Can J Neurol Sci. (46 year old man with brain tumor developed elevations in serum enzymes 3-4 months after starting dexamethasone and temozolomide [peak bilirubin 0.8 mg/dL, ALT 355 U/L, Alk P 83 U/L], liver biopsy showing steatosis and liver tests improving after reduction in corticosteroid dose).
Dixit S, Baker L, Walmsley V, Hingorani M. (2012). Temozolomide-related idiosyncratic and other uncommon toxicities: a systematic review. Anticancer Drugs. (Systematic review of rare complications of temozolomide therapy mentions 5 published cases of idiosyncratic liver injury, usually cholestatic, 3 with prolonged jaundice and one dying of liver failure).
Grant LM, Kleiner DE, Conjeevaram HS, Vuppalanchi R, Lee WM. (2013). Clinical and histological features of idiosyncratic acute liver injury caused by temozolomide. Dig Dis Sci. (Among 1000 cases of drug induced liver injury enrolled in a prospective US database between 2004 and 2011, 4 [0.5%] were attributed to temozolomide, 3 men and 1 woman, ages 47 to 70 years, with onset of injury after 25-168 days, 3 with jaundice [peak bilirubin 0.5-32 mg/dL, ALT 530-1754 U/L, Alk P 151-780 U/L], all resolving, but often with prolonged jaundice and Alk P elevations).
(2014). Temozolomide: fatal hepatic failure. Prescrire Int. (Report of fatal case of hepatotoxicity linked to temozolomide).
Becker F, Hecht M, Schmidtner J, Semrau S, Fietkau R. (2014). Temozolomide-induced liver damage. A case report. Strahlenther Onkol. (57 year old woman developed liver injury 5 weeks after starting temozolomide for glioblastoma multiforme [ALT 1997 U/L, GGT 422 U/L, bilirubin 0.5 rising to 9.5 mg/dL], resolving within 2 months, but with persistence of mild GGT elevations).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to temozolomide).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attribute to temozolomide).
Melchardt T, Magnes T, Weiss L, Grundbichler M, Strasser M, Hufnagl C, Moik M, et al. (2014). Liver toxicity during temozolomide chemotherapy caused by Chinese herbs. BMC Complement Altern Med. (56 year old woman with glioblastoma was treated with radiation therapy and temozolomide after surgery and developed jaundice one month later [bilirubin 16.7 mg/dL, ALT 585 U/L, Alk P not given], and was found to also be taking a mixture of Chinese herbs including atractylodes, astragali, mandarin orange, black cohosh, celery, kudzu, eucommia and skullcap, several of which can also cause liver injury, and patient later tolerated reintroduction of temozolomide without recurrence).
Mason M, Adeyi O, Fung S, Millar BA. (2014). Vanishing bile duct syndrome in the context of concurrent temozolomide for glioblastoma. BMJ Case Rep. (62 year old woman with glioblastoma underwent surgery and radiation therapy and developed pruritus and jaundice 15 days after starting temozolomide [bilirubin 16.9 mg/dL, ALT 747 U/L, Alk P 1402 U/L], liver biopsy showing bile duct loss [only 40% of portal areas with bile ducts], jaundice and pruritus lasting 2 months despite prompt discontinuation of temozolomide, but ultimately resolving).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5%] were attributed to antineoplastic agents including 4 due to temozolomide [Grant 2013]).
Grieco A, Tafuri MA, Biolato M, Diletto B, Di Napoli N, Balducci N, Vecchio FM, Miele L. (2015). Severe cholestatic hepatitis due to temozolomide: an adverse drug effect to keep in mind. Case report and review of literature. Medicine (Baltimore). (67 year old man with glioblastoma developed jaundice 1 month after starting temozolomide [bilirubin 7.96 rising to 25.1 mg/dL, ALT 1128 U/L, Alk P 458 U/L], with death from sepsis while still jaundiced one month later).
Balakrishnan A, Ledford R, Jaglal M. (2016). Temozolomide-induced biliary ductopenia: a case report. J Med Case Rep. (58 year old woman with glioblastoma developed jaundice 6 weeks after starting temozolomide [bilirubin 7.9 rising to 36.8 mg/dL, ALT 1028 U/L, Alk P 291 U/L], biopsy showing bile duct loss).
Aygun C, Altınok AY, Çakır A, Agan AF, Balaban Y. (2016). Acute temozolomide induced liver injury: mixed type hepatocellular and cholestatic toxicity. Acta Gastroenterol Belg. (53 year old man with glioblastoma developed jaundice after 9 weeks of temozolomide therapy [bilirubin 15.1 mg/dL, ALT 632 U/L, Alk P 1143 U/L, INR normal], biopsy showing cholestatic hepatitis, resolving 8 weeks after stopping drug).
Efferth T, Schöttler U, Krishna S, Schmiedek P, Wenz F, Giordano FA. (2017). Hepatotoxicity by combination treatment of temozolomide, artesunate and Chinese herbs in a glioblastoma multiforme patient: case report review of the literature. Arch Toxicol. (65 year old patient with glioblastoma developed fatigue, weight loss and serum enzyme elevations approximately 3 months after starting temozolomide and one month after starting several Chinese herbs including artesunate and Coptis-Kush [bilirubin not provided, ALT 157 rising to 238 U/L, GGT 29 rising to 347 U/L], with improvement upon stopping the Chinese herbs; no mention of whether temozolomide was stopped).
Khoury T, Chen S, Abu Rmeileh A, Daher S, Yaari S, Benson AA, Cohen J, et al. (2017). Acute liver injury induced by levetiracetam and temozolomide co-treatment. Dig Liver Dis. (Among 94 patients with brain tumors treated with temozolomide or levetiracetam or both, serum enzyme elevations were more common among those receiving both agents than those receiving either alone and one subject on the combination developed acute liver failure and died, compared to none receiving temozolomide alone).
Bonkovsky HL, Kleiner DE, Gu J, Odin JA, Russo MW, Navarro VM, Fontana RJ, et al., U.S. Drug Induced Liver Injury Network Investigators. (2017). Clinical presentations and outcomes of bile duct loss caused by drugs and herbal and dietary supplements. Hepatology. (Among 363 patients with acute drug induced liver injury who underwent liver biopsy, 26 had bile duct loss including 3 receiving temozolomide, all of whom had cholestatic hepatitis and a prolonged course with persistent Alk P elevations in follow up at 6-12 months).
Desai VCA, Quinlan SC, Deitz AC, He J, Holick CN, Lanes S. (2017). Risk of severe acute liver injury among patients with brain cancer treated with temozolomide: a nested case-control study using the healthcore integrated research database. J Neurooncol. (A case controlled study based upon a US health insurance research database of adults with brain tumors seen between 2006 and 2014 found no increased rates of exposure to temozolomide among 61 patients with severe acute liver injury [18%] compared to 305 matched controls [22%]).

## OTHER REFERENCE LINKS

1 Recent References on Temozolomide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Temozolomide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Temozolomide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Temozolomide)